# Antilipemic Agents

## OVERVIEW

The lipid lowering agents are used to treat hypercholesterolemia and dyslipidemias. These agents are some of the most frequently used medications in the United States. They are typically used long term and often in combination. The major effects of the lipid lowering drugs are in the lowering of serum low density lipoprotein (LDL) cholesterol levels which are believed to predispose to atherosclerosis and its complications, acute myocardial infarction, cerebrovascular ischemic stroke and peripheral vascular disease. Some of these agents also lower triglyceride levels and others may raise high density lipoprotein (HDL) cholesterol levels which are believed to be protective against atherosclerosis. The medications for dyslipidemia can be grouped into five categories: fibrates, bile acid resins, hydroxymethylglutaryl co-enzyme A (HMG-CoA) reductase inhibitors (known collectively as statins), proprotein convertase subtilisin/kexin type 9 (PCSK9) inhibitors and miscellaneous agents.

The bile acid resins or sequestrants are the oldest and safest lipid lowering agents, but are less potent than other classes now available and are not always well tolerated. The bile acid sequestrants are highly positively charged and bind to the negatively charged bile acids in the intestine, inhibiting their lipid solubilizing activity and thus reducing cholesterol absorption. They also inhibit the reabsorption of bile acids (absorption of which is typically 95%) and thus cause a contraction of the bile acid pool, which leads to increased bile acid synthesis that competes with cholesterol synthesis in the liver; this may also contribute to a lowering of cholesterol. Three bile acid sequestrants are available in the United States: cholestyramine (Questran: 1973), colestipol (Colestid: 1977) and colesevelam (Welchol: 2000). These agents are also used for therapy of pruritus for their activity in lowering the “pruritogens” that accumulate in cholestatic forms of liver disease. The bile acid resins are not absorbed and have not been linked to instances of clinically apparent liver injury. Nevertheless, some bile acid resins have been found to cause mild serum aminotransferase elevations, usually within the first months of starting therapy and without symptoms or serum bilirubin or alkaline phosphatase elevations. These serum enzyme elevations have been described most frequently after cholestyramine therapy.

Fibrates are fibric acid derivative agents and are used to lower plasma lipids and particularly triglyceride levels. Their mechanism of action is believed to be via activation of the hepatic peroxisome proliferator activated receptors (PPARs), which regulate gene transcription of enzymes involved in lipid synthesis and secretion. Three fibrates have been available and used in the United States: gemfibrozil (Lopid: 1981), fenofibrate (Lifibra, Tricor, Antara, Lipofen, Trigilde: 1993), and clofibrate (Abitrate, Atromid-S: withdrawn 2002). All three have been associated with mild-to-moderate serum aminotransferase elevations during therapy that are typically transient, asymptomatic and may resolve even with continuation. Clofibrate has been withdrawn from use because of its side effects and lack of long term effect in reducing cardiovascular mortality. Gemfibrozil and fenofibrate remain in wide scale use. Fenofibrate has been most convincingly linked to cases of clinically apparent liver injury, which can be severe and prolonged and lead to chronic liver disease and cirrhosis.

The hydroxymethylglutaryl co-enzyme A (HMG-CoA) reductase inhibitors (statins) are the most potent, best tolerated and most widely used cholesterol lowering agents and represent some of the most commonly prescribed medications in the United States. HMG-CoA reductase is the rate limiting step in cholesterol synthesis by the liver and inhibition of its activity causes a significant decrease in total and LDL cholesterol levels. The statins also have minor effects on triglyceride or HDL levels. Seven statins are available in the United States: lovastatin (Mevacor: 1987), pravastatin (Pravachol: 1991), simvastatin (Zocor: 1991), fluvastatin (Lescol: 1993), atorvastatin (Lipitor: 1996), rosuvastatin (Crestor: 2003) and pitavastatin (Levalo: 2009). All of the statins have been associated with mild-to-moderate serum aminotransferase elevations during therapy that are typically transient, asymptomatic and may resolve even with continuation. All have also been associated with rare instances of clinically apparent acute liver injury.

Proprotein convertase subtilisin/kexin type 9 (PCSK9) inhibitors are a new class of agents to treat hypercholesterolemia, which were first introduced in 2015. PCSK9 is a circulating serine protease that decreases the activity of the LDL cholesterol receptor in the liver. Blocking this receptor by circulating PCSK9 causes a decrease in the uptake of LDL cholesterol particles, resulting in an increase in LDL cholesterol in the blood. Inhibition of the activity of this protein should therefore cause a decrease in total and LDL cholesterol. Two human monoclonal antibodies to PCSK9 were developed and approved for use in the United States in 2015: alirocumab (Praluent) and evolocumab (Repatha). Treatment with these monoclonal antibodies has been shown to decrease LDL cholesterol by 50% or more in patients who have familial hypercholesterolemia (homozygotes and heterozygotes) as well as in patients who are resistant or intolerant of standard lipid lowering medications, such as the statins. The anti-PCSK9 monoclonal antibodies are typically given subcutaneously every 2 or 4 weeks. Initially, their use was limited to patients with severe hypercholesterolemia that could not be satisfactorily controlled with statins. Recently, however, they have been shown to decrease the frequency of cardiovascular events and their use is likely to expand in the future. Neither of the monoclonal anti-PCSK9 agents have been linked to episodes of clinically apparent liver injury.

The miscellaneous medications used for hypercholesterolemia or dyslipidemia include niacin, omega-3 fatty acids, ezetimibe, mipomersen and lomitapide. Niacin is a water soluble B vitamin (vitamin B3, nicotinic acid), but when used to treat dyslipidemia, it is given in doses far in excess of the minimal requirements as a vitamin. Niacin acts by reducing triglyceride synthesis via inhibition of synthesis and esterification of free fatty acids. Niacin favorably affects all aspects of dyslipidemia and is the most potent agent available for increasing HLD cholesterol levels. Niacin is available in multiple generic forms and as a combination with various statins (lovastatin: Advicor and simvastatin: Simcor). High doses of niacin are associated with a high rate of acute liver injury particularly if taken as slow release forms.

Omega-3 fatty acids are essential polyunsaturated fatty acids that have several functions in normal metabolism and health. Commonly referred to as "fish oil", many formulations of omega-3 fatty acids are available over-the-counter as nutritional supplements in support of general health. High doses of omega-3 fatty acids can lower serum triglyceride levels and several formulations have been developed as prescription medications for therapy of severe hypertriglyceridemia including omega-3 acid ethyl esters (Lovaza 2004), icosapent ethyl (Vascepa, 2012) and omega-3 carboxylic acids (Epanova, 2014). These agents have occasionally been associated with transient and mild serum enzyme elevations during treatment but have not been linked to cases of clinically apparent liver injury.

Ezetimibe (Zetia: 1999) is a lipid lowering agent that acts by inhibition of cholesterol absorption, via binding to the intestinal protein known as Neiman Pick C1 like protein 1, the major cholesterol transport protein in the intestine. Inhibition of cholesterol absorption is usually followed by an increase in hepatic cholesterol synthesis, which can be blocked by HMG-CoA reductase inhibitors. For these reasons, ezetimibe is usually used in conjunction with statins and it is often used in fixed combinations (Vytorin). Ezetimibe has been linked to a low rate of mild-to-moderate serum aminotransferase elevations during therapy and rare instances of clinically apparent acute liver injury.

Two new agents became available in 2013 for therapy of homozygous familial hypercholesterolemia, a rare but severe inborn error of metabolism marked by high levels of low density lipoprotein cholesterol and childhood onset of complications of atherosclerosis. Mipomersen (Kynamro) is an antisense oligonucleotide that binds to the mRNA that encodes apolipoprotein B. Lomitapide (Juxtapid) is an inhibitor of microsomal triglyceride transport protein which blocks production of apolipoprotein B containing lipoproteins in the liver and intestine. Both agents can lower serum cholesterol levels by 25% to 30% in patients with familial hypercholesterolemia; however, both are hepatotoxic and their use is restricted. Both mipomersen and lomitapide can cause serum aminotransferase elevations and hepatic steatosis and thus may induce or exacerbate nonalcoholic fatty liver.

The following medications for dyslipidemia and hypercholesterolemia are discussed individually in LiverTox:

- Bile Acid Resins/Sequestrants
  - Cholestyramine
  - Colesevelam
  - Colestipol
- Fibrates
  - Clofibrate
  - Fenofibrate
  - Gemfibrozil
- Monoclonal Antibodies
  - Alirocumab (Anti-PCSK9)
  - Evinacumab (Anti-ANGPTL3)
  - Evolocumab (Anti-PCSK9)
- Niacin (Nicotinic Acid)
- Omega-3 Fatty Acids,
  - Icosapent Ethyl
  - Omega-3 Acid Ethyl Esters
  - Omega-3 Carboxylic Acids
- Statins
  - Atorvastatin
  - Fluvastatin
  - Lovastatin
  - Pitavastatin
  - Pravastatin
  - Rosuvastatin
  - Simvastatin
- Miscellaneous
  - Bempedoic Acid
  - Ezetimibe
  - Inclisiran
  - Lomitapide
  - Mipomersen
  - Resmetirom

## SELECTED REFERENCES

References updated: 04 June 2019

Zimmerman HJ. Drugs used in the treatment of hypercholesterolemia and hyperlipidemia. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 660-2. (Expert review of hepatotoxicity published in 1999; mentions that the statins have dose related hepatic effects in guinea pigs and rabbits and transient elevations in aminotransferases occur in 1-5% of humans treated; several cases of clinically apparent liver injury from lovastatin and simvastatin have been published).
De Marzio DH, Navarro V. Lipid regulating agents. Hepatotoxicity of cardiovascular and antidiabetic medications. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 526-7. (Review of hepatotoxicity of lipid lowering agents).
Gurgle HE, Blumenthal DK. Drug therapy for dyslipidemias. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 605-18. (Textbook of pharmacology and therapeutics).
Law M, Rudnicka AR. Statin safety: a systematic review. Am J Cardiol 2006; 97(8A): 52C-60C. (Review of safety of statins; 38 cases of acute liver failure were submitted to MedWatch by end of 1999, which gives an estimated rate of 1 per million person-years of use; average rate of ALT elevation above 3 times ULN is 0.3% with statins compared to 0.2% in controls). 16581329
Two new drugs for homozygous familial hypercholesterolemia. Med Lett Drugs Ther 2013; 55(1413): 25-7. (Concise review of safety and efficacy of mipomersen and lomitapide shortly after their approval in the US; both can lower low density lipoprotein levels in persons with familial hypercholesterolemia, but "Both are hepatotoxic and very expensive"). 23545581
Drugs for hypertriglyceridemia. Med Lett Drugs Ther 2013; 55 (1411): 17-9. (Concise review of drugs approved for therapy of hypertriglyceridemia including fibrates, niacin and fish oil; mentions risk of liver injury with fibrates and niacin, but not fish oils or omega-3 fatty acids). 23467119
Navarese EP, Kolodziejczak M, Schulze V, Gurbel PA, Tantry U, Lin Y, Brockmeyer M, et al. Effects of proprotein convertase subtilisin/kexin type 9 antibodies in adults with hypercholesterolemia: a systematic review and meta-analysis. Ann Intern Med 2015; 163: 40-51. (Systematic review of the literature on efficacy and safety of anti-PCSK9 monoclonal antibody therapy [both alirocumab and evolocumab] in patients with hypercholesterolemia concludes that these agents are safe and effective, leading to marked reductions in LDL cholesterol without increasing serious adverse events; does not discuss ALT elevations or hepatotoxicity). 25915661
Lipid-lowering drugs. Med Lett Drugs Ther 2016; 58(1506): 133-40. (Review of safety and efficacy of cholesterol and triglyceride lowering agents including statins, fibrates, niacin, ezetimibe, omega-3 fatty acids, bile acid sequestrants and PCSK9 inhibitors; mentions that ALT elevations and liver injury can occur with statins, ezetimibe, niacin and the fibrates). 27755510